# Bictegravir

## OVERVIEW

### Introduction

Bictegravir is a human immunodeficiency virus (HIV) integrase strand transfer inhibitor, the fourth in this class of agents that target the viral integrase. Bictegravir is used only in combination with other antiretroviral agents in the treatment of HIV infection and it has had limited use. Bictegravir is associated with a low rate of serum aminotransferase elevations during therapy, but has not been linked to instances of acute, clinically apparent liver injury.

### Background

Bictegravir (bic teg' ra vir) is a relatively new antiretroviral drug that targets the HIV integrase, one of the three viral enzymes involved in replication. Bictegravir blocks the binding site of the HIV integrase and prevents the strand transfer activity and integration of the provirus into the host genome. Bictegravir has both in vitro and in vivo activity against HIV, and several randomized controlled trials have shown that it in combination with other antiretroviral agents can cause significant declines in HIV RNA levels and rises in peripheral CD4 T cell counts, demonstrating non-inferiority to established combination antiretroviral regimens of proven efficacy. Bictegravir (50 mg) in a fixed combination with emtricitabine (200 mg) and tenofovir alafenamide (25 mg) under the brand name Biktarvy was approved for use in HIV infection in the United States in 2018 and is currently used in an increasing proportion of antiretroviral regimens. The recommended dose is one tablet daily. Unlike the other integrase strand transfer inhibitors, bictegravir has not been marketed by itself to allow combination with other antiretroviral agents. Combination of Biktarvy with other antiretroviral agents is not recommended nor its use in patients with severe renal or liver dysfunction. While generally well tolerated, bictegravir therapy may be accompanied by diarrhea, headache, nausea and fever.

### Hepatotoxicity

In large clinical trials, therapy with bictegravir combined with emtricitabine and tenofovir alafenamide was associated with alanine aminotransferase (ALT) elevations (above 1.5 times ULN) in 11% patients, but these rates were similar to those in comparator groups (12% to 15%) receiving matched background optimized antiretroviral therapy without bictegravir. Elevations above 5 times ULN occurred in only 1.4% of bictegravir vs 0.9% to 1.3% of control comparator arm subjects. The elevations were not associated with clinical symptoms and generally did not require dose modification. In addition, there were no instances of acute hepatocellular liver injury with jaundice. The product label for bictegravir mentions acute exacerbations of hepatitis B and hepatic failure as potential adverse reactions when bictegravir with emtricitabine and tenofovir is discontinued. This adverse reaction can occur upon discontinuation of any antiretroviral regimen with concurrent activity against HBV and represents the effects of tenofovir and emtricitabine. Nevertheless, since its approval and its more widescale use, there have been no published reports of clinically apparent cases of liver injury or exacerbation of hepatitis B convincingly attributed to bictegravir.

Likelihood score: E* (unproven but suspected potential cause of liver injury).

### Mechanism of Injury

The mechanism by which bictegravir might cause liver injury is not known. Bictegravir is metabolized by the liver, largely by glucuronidation with subsequent urinary clearance. Bictegravir has little or no effect on microsomal cytochrome P450 enzymes. Reconstitution of immune reactivity by antiretroviral therapy in patients with an underlying chronic hepatitis B or C can be associated with a transient flare of hepatitis. Discontinuation of antiretroviral therapy with concurrent activity against HBV can cause severe exacerbations of hepatitis B.

### Outcome and Management

If bictegravir hepatotoxicity occurs, it must be rare. Bictegravir has not been linked to cases of acute liver failure, chronic hepatitis or vanishing bile duct syndrome. Patients receiving antiviral therapy for HIV infection should be screened for evidence of hepatitis B and C and treated accordingly.

Drug Class: Antiviral Agents

Other Drugs in the Subclass, Integrase Strand Transfer Inhibitors: Cabotegravir, Dolutegravir, Elvitegravir, Raltegravir

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Bictegravir – Biktarvy®

(Bictegravir, Emtricitabine and Tenofovir Alafenamide Combination Product)

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Bictegravir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Bictegravir | 1611493-60-7 | C21-H18-F3-N3-O5
Dolutegravir | 1051375-16-6 | C20-H19-F2-N3-O5
Elvitegravir | 697761-98-1 | C23-H23-Cl-F-N-O5
Raltegravir | 518048-05-0 | C20-H21-F-N6-O5

## ANNOTATED BIBLIOGRAPHY

References updated: 10 April 2019

Núñez M. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 505-18. (Review of hepatotoxicity of antiviral agents including drugs for HIV infection, although the integrase strand transfer inhibitors are not discussed).
Flexner C. Antiretroviral agents and treatment of HIV infection. In, Brunton LL, Hillal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1137-57. (Textbook of pharmacology and therapeutics).
https://hivinfo.nih.gov/hiv-source/medical-practice-guidelines/hiv-treatment-guidelines (Regularly updated clinical guidelines on the use of antiretroviral agents in HIV-1 infected adults, adolescents and children).
Cocohoba J, Dong BJ. (2008). Raltegravir: the first HIV integrase inhibitor. Clin Ther. (Review of the mechanism of action, pharmacokinetics and phase I-III studies of raltegravir; in combined phase III studies, ALT elevations above 5 times ULN occurred in 4.3% of 462 raltegravir treated vs 3.4% of 237 placebo treated patients who were receiving optimized background therapy; no hepatic serious adverse events were reported).
Surgers L, Lacombe K. (2013). Hepatoxicity of new antiretrovirals: a systematic review. Clin Res Hepatol Gastroenterol. (Review of evidence of liver injury in large clinical trials of newer antiretroviral agents including dolutegravir but not bictegravir concluded that "the overall hepatic tolerance is far better with the novel drugs in this review than with former ARV regimens"; ALT elevations occurred with equal frequency in dolutegravir and comparator arms, and one patient on raltegravir developed DRESS syndrome).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 12 [1.3%] cases were attributed to antiretroviral agents, but none to the integrase inhibitors–dolutegravir, elvitegravir, raltegravir or bictegravir).
Sax PE, Pozniak A, Montes ML, Koenig E, DeJesus E, Stellbrink HJ, Antinori A, et al. (2017). Coformulated bictegravir, emtricitabine, and tenofovir alafenamide versus dolutegravir with emtricitabine and tenofovir alafenamide, for initial treatment of HIV-1 infection (GS-US-380-1490): a randomised, double-blind, multicentre, phase 3, non-inferiority trial. Lancet. (Among 657 previously untreated adults with HIV infection who were started on combination antiretroviral therapy with bictegravir or dolutegravir with tenofovir and emtricitabine, HIV RNA suppression was similar in the two groups [89% vs 93%] as were the rates of adverse events, including ALT levels above 5 times ULN [2% vs 1%] which were usually attributable to concurrent hepatitis B or C).
Gallant J, Lazzarin A, Mills A, Orkin C, Podzamczer D, Tebas P, Girard PM, et al. (2017). Bictegravir, emtricitabine, and tenofovir alafenamide versus dolutegravir, abacavir, and lamivudine for initial treatment of HIV-1 infection (GS-US-380-1489): a double-blind, multicentre, phase 3, randomised controlled non-inferiority trial. Lancet. (Among 631 adults with previously untreated HIV infection started on single tablet regimens, viral control [HIV RNA <500 copies/mL] at 48 weeks was similar with bictegravir/emtricitabine/tenofovir [92%] as with dolutegravir/abacavir/lamivudine [93%], while adverse event rates were slightly less, including discontinuations for adverse events [0% vs 1.3%], serious adverse events [6% vs 8%] and ALT elevations above 5 times ULN [0.6% vs 1.3%]).
Daar ES, DeJesus E, Ruane P, Crofoot G, Oguchi G, Creticos C, Rockstroh JK, et al. (2018). Efficacy and safety of switching to fixed-dose bictegravir, emtricitabine, and tenofovir alafenamide from boosted protease inhibitor-based regimens in virologically suppressed adults with HIV-1: 48-week results of a randomised, open-label, multicentre, phase 3, non-inferiority trial. Lancet HIV. (Among 577 adults with HIV infection switched to Biktarvy [bictegravir/ emtricitabine/ tenofovir] or maintained on previous combination regimen, HIV RNA suppression was similar in the two groups, as were overall as well as serious adverse event rates, ALT elevations above 5 times ULN occurring in 1% vs 2%).
Molina JM, Ward D, Brar I, Mills A, Stellbrink HJ, López-Cortés L, Ruane P, et al. (2018). Switching to fixed-dose bictegravir, emtricitabine, and tenofovir alafenamide from dolutegravir plus abacavir and lamivudine in virologically suppressed adults with HIV-1: 48-week results of a randomised, double-blind, multicentre, active-controlled, phase 3, non-inferiority trial. Lancet HIV. (Among 563 adults with HIV infection switched to bictegravir/emtricitabine/tenofovir or maintained on previous combination regimen, HIV RNA suppression was similar in the two groups [both 99%], as were overall [80% vs 80%] as well as serious adverse event rates [5% vs 8%], ALT elevations above 5 times ULN occurring in 2% vs 0%, all abnormalities occurring in patients with underlying pre-existing liver disease).
Markham A. (2018). Bictegravir: first global approval. Drugs. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy and safety of bictegravir; mentions that elevations in serum ALT levels above 5 times ULN occurred in 1-2% of patients treated with bictegravir in clinical trials).
(2018). Biktarvy--another INSTI-based combination for HIV. Med Lett Drugs Ther. (Concise review of the mechanism of action, efficacy, safety and costs of bictegravir combined with tenofovir and emtricitabine [Biktarvy]; mentions the flares of hepatitis B in co-infected subjects can occur when the combination is stopped).

## OTHER REFERENCE LINKS

1 Recent References on Bictegravir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Bictegravir/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2 Trials on Bictegravir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Bictegravir)